# Omaveloxolone

## OVERVIEW

### Introduction

Omaveloxolone is an oral, small molecule activator of Nrf2 that targets inflammatory, metabolic and oxidative stress pathways and has been approved for use in Friedreich ataxia, a severe genetic disease marked by progressive muscle incoordination and weakness. Omaveloxolone therapy is associated with transient, mild-to-moderate serum aminotransferase levels during therapy but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Omaveloxolone (oh ma vel ox” oh lone) is an orally available, small molecule activator of nuclear factor (erythroid-derived 2)-like 2 (Nrf2) that stimulates gene pathways involved in antioxidative and antiinflammatory responses, and is used to treat Friedreich ataxia, a severe genetic disease marked by progressive incoordination, muscle loss, and weakness. Friedreich ataxia is caused by a defect in the frataxin gene due to repeated and excessive expansion of GAA codons which results in iron-sulfur clusters within mitochondria leading to oxidative stress, inflammation, and cellular damage. The Nrf2 pathway is reduced in patients with Friedreich ataxia resulting in excessive oxidative stress and mitochondrial injury in muscle. Omaveloxolone is a semi-synthetic triterpenoid that activates the Nrf2 pathway and was shown to stimulate Nrf2 in cell culture and in animal models of Friedreich ataxia and other conditions marked by oxidative stress. In a prospective, placebo-controlled trial, omaveloxolone improved symptoms and was associated with a lack of progression in muscle weakness. Omaveloxolone was approved in the United States for use in adults and adolescents 16 years of age or older with Friedreich ataxia in 2023. Omaveloxolone is available in capsules of 50 mg under the brand name Skyclarys. The recommended dose is 150 mg (3 capsules) once daily. A lower dose can be used in response to adverse events and as initial therapy in patients with preexisting moderate hepatic impairment. Side effects can include headache, nausea, abdominal pain, diarrhea, fatigue, and musculoskeletal pain. Laboratory abnormalities include a high rate of ALT and AST elevation and hyperlipidemia. Severe adverse events are uncommon but can include marked cholesterol elevations and fluid overload. Monitoring of serum aminotransferase and cholesterol levels during therapy is recommended.

### Hepatotoxicity

In the prelicensure clinical trials in 82 patients with Friedreich ataxia, serum aminotransferase elevations occurred in 37% of treated compared to 2% of placebo recipients and were above 5 times ULN in 16% vs 0%. The ALT and AST elevations, however, were not accompanied by symptoms or bilirubin elevations and appeared to be due to induction of the serum enzymes (ALT, AST, and GGT) rather than liver injury. Aminotransferase elevations often improved during continued therapy. Nevertheless, monitoring of serum aminotransferase and bilirubin levels is recommended at least during the first 3 months of therapy. In the prelicensure clinical studies and subsequently after approval of omaveloxolone, there have been no reports of clinically apparent liver injury with jaundice linked to its use. However, Friedreich ataxia is a rare disease and clinical experience with use of omaveloxolone has been limited.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations during omaveloxolone therapy are believed to be due to enzyme induction. The frequency of the elevations is dose related and was observed in experimental animals in preclinical studies with no histologic evidence of damage to the liver. Omaveloxolone is metabolized in the liver largely by cytochrome 3A4, and it is susceptible to drug-drug interactions with moderate or strong inducers or inhibitors of CYP 3A4 concurrent use of which should be avoided.

### Outcome and Management

Monitoring of laboratory tests including ALT, AST, GGT, and bilirubin levels is recommended before, every month for 3 months, and then periodically thereafter. Elevations above 5 times the ULN should lead to temporary discontinuation, and any elevations in aminotransferase levels accompanied by jaundice or symptoms of liver disease to prompt discontinuation. Omaveloxolone should not be used in patients with severe hepatic disfunction (Child Pugh C) and started at a lower dose in those with moderate dysfunction (Child Pugh B).

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omaveloxolone – Skyclarys®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Omaveloxolone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Omaveloxolone | 1474034-05-3 | C33-H44-F2-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 09 February 2025

Abbreviations: Nfr2, nuclear factor, erythroid 2-like 2; ULN, upper limit of normal.

FDA. Clinical Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216718Orig1s000MedR.pdf (FDA website with medical review of efficacy and safety of omaveloxolone submitted in support of its approval for use in Friedreich ataxia, mentions that in registration trials in adults and children with Friedreich ataxia there were no liver related serious adverse events, and although ALT elevations arose in 37% and were above 5 times the upper limit of normal [ULN] in 16% of patients, serum bilirubin and albumin levels remained normal and the elevations were attributed to enzyme induction rather than liver cell injury).
Lynch DR, Farmer J, Hauser L, Blair IA, Wang QQ, Mesaros C, Snyder N, et al. Safety, pharmacodynamics, and potential benefit of omaveloxolone in Friedreich ataxia. Ann Clin Transl Neurol. 2018;6:15-26. (Among 69 patients with Friedreich ataxia treated with 1 of 8 dose regimens of omaveloxolone daily for 12 weeks, the optimal dose in affecting clinical symptoms was between 80 and 160 mg daily and adverse events were generally mild, although elevations in serum ALT and AST arose in 12% of patients but these were dose related and occurred without symptoms or increases in serum bilirubin suggesting that they were caused by induction of the enzymes by Nrf2 activation). 30656180
Reisman SA, Ferguson DA, Lee CI, Proksch JW. Omaveloxolone and TX63682 are hepatoprotective in the STAM mouse model of nonalcoholic steatohepatitis. J Biochem Mol Toxicol. 2020;34:e22526. (In a mouse model of nonalcoholic fatty liver disease, administration of omaveloxolone led to a decrease in hepatic fat and inflammation but increases in ALT, AST, and GTT values but not bilirubin suggesting that the ALT elevations were due to direct effect of the drug [induction of Nrf2 target gene expression] and not liver injury). 32410268
Lynch DR, Chin MP, Delatycki MB, Subramony SH, Corti M, Hoyle JC, Boesch S, et al. Safety and efficacy of omaveloxolone in Friedreich ataxia (MOXIe Study). Ann Neurol. 2021; 89: 212-225. (Among 82 patients with Friedreich ataxia [ages 16 to 40 years] treated with omaveloxolone [150 mg] vs placebo once daily for 48 weeks, therapy was associated with improved symptom scores while common adverse events include headache [37% vs 25%], nausea [33% vs 14%], and ALT elevations [37% vs 2%], which were above 3 times ULN in 29% vs 0%, but the elevations were likely due to enzyme induction rather than liver damage, because none were associated with bilirubin elevations or symptoms). 33068037
Lee A. Omaveloxolone: first approval. Drugs. 2023;83:725-729. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and toxicity of omaveloxolone shortly after its approval for use in Friedreich ataxia mentions that ALT or AST elevations arose in 37% of treated patients vs 2% of controls and were above 5 times ULN in 16% vs 0%, but the elevations were generally asymptomatic and reversible following discontinuation). 37155124
Pilotto F, Chellapandi DM, Puccio H. Omaveloxolone: a groundbreaking milestone as the first FDA-approved drug for Friedreich ataxia. Trends Mol Med. 2024;30:117-125. (Review of the mechanism of action and clinical efficacy of omaveloxolone as therapy of Friedreich ataxia; no discussion of adverse events). 38272714
Naghipour S, Corben LA, Hulme AJ, Dottori M, Delatycki MB, Lees JG, Lim SY. Omaveloxolone for the treatment of Friedreich ataxia: efficacy, safety, and future perspectives. Mov Disord. 2025;40(2):226-230. (Review of the mechanism of action of omaveloxolone and its effects in Friedreich ataxia states that therapy improves mitochondrial function, antioxidant status, and symptom rating scales in Friedreich ataxia but its role in improving or preventing cardiac complications has not been shown; comments that “liver function should be closely observed” due to the potential of elevations in serum aminotransferase levels). 39559924

## OTHER REFERENCE LINKS

1. Recent References on Omaveloxolone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Omaveloxolone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Omaveloxolone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Omaveloxolone)